# Ribavirin

## OVERVIEW

### Introduction

Ribavirin is a nucleoside analogue and antiviral agent used in therapy of chronic hepatitis C and other flavivirus infections. Ribavirin has not been associated with clinically apparent liver injury.

### Background

Ribavirin (rye" ba vye' rin) is a guanosine nucleoside analogue which has antiviral activity against many RNA and DNA viruses in vitro, but has been found to have clinical effects in humans mostly against flaviviruses, including the hepatitis C virus (HCV), respiratory syncytial virus (RSV), and perhaps the Ebola and Hanta viruses. The in vitro antiviral activity of ribavirin appears to be mediated by depletion of intracellular guanosine through inhibition of inosine monophosphate dehydrogenase (a necessary enzyme in purine nucleoside synthesis). Ribavirin may also have indirect effects on viral replication caused by increasing interferon induced gene expression and modulating immune responses. Ribavirin is indicated as adjunctive therapy with alpha interferon or peginterferon in combination with an HCV specific protease inhibitor (boceprevir or telaprevir) in chronic hepatitis C. Ribavirin is also used by inhalation for acute RSV infection. Ribavirin has been used experimentally to treat chronic hepatitis E, and is currently under evaluation in interferon-free regimens for hepatitis C in combination with other oral direct acting antivirals. Ribavirin was approved for use in hepatitis C in 1998 and was initially widely used for that indication. With the development of potent, all oral, direct acting antiviral agents for hepatitis C, ribavirin has been used far less frequently, although it is occasionally still used in patients who relapse or fail to respond to optimal direct acting agents for hepatitis C. Ribavirin is available as capsules of 200 mg in generic forms and under the brand names of Copegus and Rebetol. The recommended dose of ribavirin in adults is 800 to 1200 mg daily in two divided doses for 24 to 48 weeks in combination with peginterferon, with or without boceprevir or telaprevir. Side effects include hemolytic anemia, pruritus and nasal stuffiness.

### Hepatotoxicity

Oral therapy with ribavirin alone is rarely used and has not been associated with serum aminotransferase elevations. Because ribavirin is usually used in patients with underlying liver disease (hepatitis C), it is difficult to interpret increases in serum ALT levels during therapy, and typically ribavirin decreases serum ALT levels in patients with hepatitis C. Ribavirin does cause a dose dependent red cell hemolysis which can be severe. The onset of hemolysis is usually after 2 to 3 weeks of therapy and can present with symptoms of anemia and sudden decreases in hematocrit levels by 5% to 10%. The hemolysis is accompanied by a mild increase in indirect bilirubin, which may result in total bilirubin concentrations of 1.5 to 2.5 mg/dL. This indirect hyperbilirubinemia is generally benign and resolves rapidly once therapy is stopped. Patients with underlying Gilbert syndrome or with advanced liver disease may become visibly jaundiced. Patients with deficiencies in inosine triphosphatase activity (ITPA variants) are relatively protected against the hemolysis of ribavirin, probably because the increased levels of intracellular ITP provide an alternate source for intracellular guanosine and adenosine triphosphate which are depleted in red cells by ribavirin-triphosphate.

Rare instances of fatty liver with lactic acidosis and hepatic dysfunction have been reported in patients with HIV infection receiving antiretroviral therapy as well as ribavirin in combination with interferon or oral direct acting antiviral agents against hepatitis C. This complication has not been reported with use of ribavirin alone and drug-drug interactions are likely the cause, ribavirin increasing the risk of lactic acidosis from other nucleoside analogues used in the treatment of HIV infection (particularly stavudine, didanosine and zidovudine).

Treatment of patients with advanced cirrhosis with chronic hepatitis C using potent direct acting antiviral agents has resulted in several instances of acute hepatic decompensation, typically arising during the first few weeks of treatment. Many of these patients were also receiving ribavirin, but sudden decompensation has also been described in non-ribavirin containing regimens and no single antiviral agent appears to be responsible. Because ribavirin is generally used in combination with other antiviral agents its contribution to adverse events and particularly liver associated adverse events is difficult to assess. If ribavirin is capable of causing significant liver injury, this must be quite rare.

Likelihood score: E* (unproven although suspected rare cause of clinically apparent liver injury)

### Mechanism of Injury

Ribavirin is metabolized minimally by the liver and is excreted largely unchanged by the kidneys, perhaps accounting for the absence or rarity of hepatic injury. The hyperbilirubinemia associated with ribavirin use is due to red cell hemolysis and excess production of bilirubin.

Drug Class: Antiviral Agents, Nucleoside Analogues, Hepatitis C Agents

## CASE REPORT

### Case 1. Hyperbilirubinemia during ribavirin therapy in a patient with Gilbert syndrome.

[NIH Case #R52]

A 53 year old man with chronic hepatitis C developed mild jaundice during experimental therapy with ribavirin. He was known to have had chronic hepatitis C for 10 years, acquired because of a blood transfusion. He was otherwise well, but had a previous history of hepatitis B from which he had recovered. He denied all symptoms of liver disease except for mild and intermittent fatigue. He had elevations of serum aminotransferase levels (ALT 123 U/L, AST 91 U/L), but normal serum bilirubin 0.9 mg/dL and albumin 4.2 g/dL. He was positive for anti-HCV, and HCV RNA was present at levels of 3 to 6 million IU/mL, genotype 1b. HBsAg and anti-HAV were negative and autoantibodies were not detected. A liver biopsy showed marked disease activity (histology activity index score of 12 of a total possible of 18) and bridging hepatic fibrosis (Ishak fibrosis score of 3 of a possible 6). He was enrolled in an experimental study of ribavirin monotherapy and received 1200 mg daily for 12 months. Serum enzymes improved during treatment, but serum bilirubin levels were intermittently elevated with a peak total bilirubin of 3.1, direct 0.5 mg/dL. A concurrent reticulocyte count had risen from 2.4 to 9.3% and hematocrit had fallen from 49.2% to 39.7% (Table). He denied worsening of fatigue or itching. Upon stopping ribavirin, the hemolysis resolved and bilirubin levels and reticulocyte counts fell while serum aminotransferase levels and hematocrit rose to baseline levels. There was no sustained improvement in the liver disease.

#### Key Points

Medication: | Ribavirin (1200 mg daily)
Pattern: | Not applicable
Severity: | None; hyperbilirubinemia without liver injury
Latency: | 2-4 weeks
Recovery: | 2-4 weeks
Other medications: | None

#### Laboratory Values

Months After Starting | ALT (U/L) | Total Bilirubin (mg/dL) | Retics (%) | Hct (%) | HCV RNA (million IU/mL)
Pre | 123 | 0.9 | 1.0 | 50.3 | 6.5
0 | 148 | 1.5 | 2.4 | 49.2 | 3.4
Ribavirin (1200 mg daily) started
1 | 85 | 1.7 | 8.8 | 41.0 | 2.6
2 | 65 | 2.0 | 9.3 | 39.7 | 2.5
4 | 35 | 2.1 | 10.4 | 36.4 | 2.5
6 | 47 | 1.5 | 11.7 | 38.8 | 1.9
8 | 54 | 3.1 | 9.3 | 39.7 | 1.8
12 | 43 | 1.9 | 9.9 | 37.9 | 1.8
Ribavirin stopped and patient followed on no therapy
+1 | 72 | 0.6 | 2.4 | 48.0
+2 | 212 | 0.8 | 1.3 | 48.6 | 3.0
+6 | 157 | 1.4 | 1.3 | 49.0
Normal Values | <42 | <1.2 | <1.0 | >38 | None

Abbreviations: Retics, reticulocytes; Hct, hematocrit; HCV, hepatitis C virus.

#### Comment

A patient with chronic hepatitis C and probable Gilbert syndrome (constitutional indirect hyperbilirubinemia) developed visible jaundice during an experimental study of monotherapy with ribavirin. At the same time that serum bilirubin levels increased, serum ALT levels had fallen in response to the ribavirin therapy. There was a concomitant minor decrease in HCV RNA levels. The increase in indirect hyperbilirubinemia with reticulocytosis and decrease in hematocrit indicated that the jaundice was due to hemolysis in a patient with impaired ability to conjugate bilirubin, rather than hepatic injury or cholestasis. There was a rapid reversal of the hyperbilirubinemia with stopping therapy. Both before and after therapy, total serum bilirubin levels were occasionally slightly above normal (1.5-1.8 mg/dL), probably based upon how long he had been fasting at the time of the blood draw.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ribavirin – Generic, Copegus®, Rebetol®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ribavirin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ribavirin | 36791-04-5 | C8-H12-N4-O5 | Ribavirin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2018

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that ribavirin can cause hemolysis and hyperbilirubinemia, but "no other evidence of hepatic injury").
Spengler U. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 567-91. (Review of hepatotoxicity of antiviral agents published in 2007).
Hayden. Antiviral agents (nonretroviral). In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1243-72. (Textbook of pharmacology and therapeutics).
Di Bisceglie AM, Conjeevaram HS, Fried MW, Sallie R, Park Y, Yurdaydin C, Swain M, et al. Ribavirin as therapy for chronic hepatitis C. A randomized, double-blind, placebo-controlled trial. Ann Intern Med 1995; 123: 897-903. (Controlled trial of 12 month course of ribavirin vs placebo in 29 patients with chronic hepatitis C; serum aminotransferase levels decreased in all but one ribavirin treated patient; none developed worsening of liver disease: Case 1). 7486483
Fried MW. Side effects of therapy of hepatitis C and their management. Hepatology 2002; 36 (5 Suppl 1): S237-44. (Review of side effects of interferon and ribavirin). 12407599
Soriano V, Miralles C, Berdú, Berdun MA, Losada E, Aguirrebenjoa K, Ocampo A, et al.; PRESCO Study Group. Premature treatment discontinuation in HIV/HCV-coinfected patients receiving pegylated interferon plus weight-based ribavirin. Antivir Ther 2007; 12: 469-76. (Among 389 patients with HIV-HCV coinfection treated with peginterferon and ribavirin in Spain, 45% stopped therapy early, 2 developed mitochondrial injury with pancreatitis and lactic acidosis [despite not using didanosine], resolving with stopping therapy). 17668555
Drugs for non-HIV viral infections. Treat Guidel Med Lett 2007; 5: 59-70. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for ribavirin). 17565338
Jain MK, Zoellner C. Role of ribavirin in HCV treatment response: now and in the future. Expert Opin Pharmacother 2010; 11: 673-83. (Review of the chemistry, mechanism of action, pharmacokinetics, clinical efficacy and side effects of ribavirin in chronic hepatitis C; ribavirin is used only in combination with interferon or peginterferon; major side effect is hemolysis; ribavirin and peginterferon may predispose patients with HIV infection also receiving antiretroviral nucleoside analogues such as stavudine to develop lactic acidosis). 20163278
Kamar N, Rostaing L, Abravanel F, Garrouste C, Lhomme S, Esposito L, Basse G, et al. Ribavirin therapy inhibits viral replication on patients with chronic hepatitis E virus infection. Gastroenterology 2010; 139: 1612-8. (Among six patients with chronic hepatitis E treated with ribavirin [400-800 mg daily], all became HEV RNA negative during therapy and 4 remained negative afterwards; side effects included hemolysis and anemia, but serum ALT levels improved in all patients). 20708006
Fellay J, Thompson AJ, Ge D, Gumbs CE, Urban TJ, Shianna KV, Little LD, et al. ITPA gene variants protect against anaemia in patients treated for chronic hepatitis C. Nature 2010; 464: 405-8. (Genome wide association study in 1602 patients with chronic hepatitis C treated with peginterferon and ribavirin found that variants leading to inosine triphosphatase deficiency were associated with protection against ribavirin associated hemolysis). 20173735
Hitomi Y, Cirulli ET, Fellay J, McHutchison JG, Thompson AJ, Gumbs CE, Shianna KV, et al. Inosine triphosphate protects against ribavirin-induced adenosine triphosphate loss by adenylosuccinate synthase function. Gastroenterology 2011; 140: 1314-21. (Analysis of role of inosine triphosphate [ITP] in protecting against hemolysis caused by ribavirin, suggesting that ITP provides an alternate source for guanosine and adenosine triphosphate, which are depleted by build up of ribavirin triphosphate in red cells). 21199653
Poordad F, McCone J Jr, Bacon BR, Bruno S, Manns MP, Sulkowski MS, Jacobson IM, et al.; SPRINT-2 Investigators. Boceprevir for untreated chronic HCV genotype 1 infection. N Engl J Med 2011; 364: 1195-206. (Among 734 patients with chronic hepatitis C, genotype 1, treated with boceprevir, peginterferon and ribavirin for 28-48 weeks, sustained reponse rates were 63-66%; adverse events included hemolysis and anemia, but no worsening liver enzyme levels or flares of hepatitis mentioned). 21449783
Jacobson IM, McHutchison JG, Dusheiko G, Di Bisceglie AM, Reddy KR, Bzowej NH, Marcellin P, et al.; ADVANCE Study Team. Telaprevir for previously untreated chronic hepatitis C virus infection. N Engl J Med 2011; 364: 2405-16. (Among 727 patients with chronic hepatitis C, genotype 1, treated with the combination of telaprevir, peginterferon and ribavirin, sustained response rates were 69-75%; adverse events included hemolysis and anemia, but no worsening of liver enzyme levels or flares of hepatitis mentioned). 21696307
Gane EJ, Stedman CA, Hyland RH, Ding X, Svarovskaia E, Symonds WT, Hindes RG, et al. Nucleotide polymerase inhibitor sofosbuvir plus ribavirin for hepatitis C. N Engl J Med 2013; 368: 34-44. (Among 85 patients with chronic hepatitis C treated with sofosbuvir and ribavirin with or without peginterferon for 8-12 weeks, serum enzymes became or remained normal and HCV RNA became undetectable in all patients during therapy; adverse events included anemia and hemolysis, but there were no instances of worsening of liver enzymes or flares of hepatitis). 23281974
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to ribavirin or oral direct acting agents used to treat hepatitis C). 25754159
Reddy KR, Bourlière M, Sulkowski M, Omata M, Zeuzem S, Feld JJ, Lawitz E, et al. Ledipasvir and sofosbuvir in patients with genotype 1 hepatitis C virus infection and compensated cirrhosis: An integrated safety and efficacy analysis. Hepatology 2015; 62: 79-86. (Among 513 cirrhotic patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin for 12 or 24 weeks in 7 clinical trials, the overall SVR rate was 96% and there were 24 [5%] serious adverse events, only 5 [1%] of which were considered treatment related, none of which were liver related). 25846144
Mizokami M, Yokosuka O, Takehara T, Sakamoto N, Korenaga M, Mochizuki H, Nakane K, et al. Ledipasvir and sofosbuvir fixed-dose combination with and without ribavirin for 12 weeks in treatment-naive and previously treated Japanese patients with genotype 1 hepatitis C: an open-label, randomised, phase 3 trial. Lancet Infect Dis 2015; 15: 645-53. (Among 341 Japanese patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and ledipasvir with or without ribavirin for 12 weeks, SVR rates were 98% and 100%, adverse events were more common in those receiving ribavirin [75% vs 65%]; there were no liver related severe adverse events attributed to therapy or ALT elevations above 5 times ULN). 25863559
Charlton M, Everson GT, Flamm SL, Kumar P, Landis C, Brown RS Jr, Fried MW, et al.; SOLAR-1 Investigators. Ledipasvir and sofosbuvir plus ribavirin for treatment of HCV infection in patients with advanced liver disease. Gastroenterology 2015; 149: 649-59. (Among 337 patients with chronic hepatitis C, genotype 1 or 4, with decompensated cirrhosis treated with sofosbuvir, ledipasvir and ribavirin for 12 or 24 weeks, SVR rates were 86-89%, but serious adverse events were frequent [23%] and included hepatic decompensation, need for liver transplantation and death [2.6%]). 25985734
Saxena V, Nyberg L, Pauly M, Dasgupta A, Nyberg A, Piasecki B, Winston B, et al. Safety and Efficacy of simeprevir/sofosbuvir in hepatitis C-infected patients with compensated and decompensated cirrhosis. Hepatology 2015; 62: 715-25. (Among 156 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with simeprevir and sofosbuvir with or without ribavirin for 12 weeks, overall SVR rates were 91% in compensated vs 73% in decompensated cases, and worsening decompensation in 20% vs 3%, one patient dying of liver failure, but rates of adverse events were said to be similar to those of a matched cohort of untreated subjects). 26033798
Kalafateli M, Dusheiko G, Manousou P. Clinical decompensation after achieving SVR with sofosbuvir, daclatasvir and ribavirin in a patient with recurrent HCV post-liver transplant. J Gastrointestin Liver Dis 2015; 24: 257-8. (33 year old man with hemophilia and chronic hepatitis C, genotype 3, underwent liver transplantation and had recurrence of hepatitis C which failed to respond to several courses of peginterferon, eventually achieving an SVR with sofosbuvir, daclatasvir and ribavirin, but then developing hepatic decompensation 2 months later). 26114189
Foster GR, Pianko S, Brown A, Forton D, Nahass RG, George J, Barnes E, et al.; BOSON Study Group. Efficacy of sofosbuvir plus ribavirin with or without peginterferon-alfa in patients with hepatitis C virus genotype 3 infection and treatment-experienced patients with cirrhosis and hepatitis C virus genotype 2 infection. Gastroenterology 2015 149: 1462-70. (Among 592 patients with chronic hepatitis C, genotype 2 or 3, treated with sofosbuvir and ribavirin for 16 or 24 weeks or sofosbuvir, ribavirin and peginterferon for 12 weeks, the SVR rates were 87-100% in genotype 2 and 71-93% in genotype 3 patients; serious adverse events occurred in 4-6%, but none were hepatic decompensation or hepatitis and most were considered unrelated to sofosbuvir; ALT elevations above 5 times ULN occurred in 9 patients [1.5%], but were self-limited and did not result in early discontinuation of therapy). 26248087
Sulkowski MS, Vargas HE, Di Bisceglie AM, Kuo A, Reddy KR, Lim JK, Morelli G, et al.; HCV-TARGET Study Group. Effectiveness of simeprevir plus sofosbuvir, with or without ribavirin, in real-world patients with HCV genotype 1 infection. Gastroenterology 2016; 150: 419-29. (Among 802 patients with chronic hepatitis C, genotype 1, treated with sofosbuvir and simeprevir with or without ribavirin for 12 weeks in clinical practices ["the real world"], 675 [84%] had an SVR, 44 [5.3%] had a serious adverse event, 10 [1.2%] hepatic decompensation and 2 [0.3%] died of liver failure). 26497081
Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol 2016; 64: 753-4. (74 year old man and 36 year old woman with HCV related cirrhosis developed worsening hepatic decompensation within a few weeks of starting sofosbuvir, an NS5A inhibitor and ribavirin [peak bilirubin 23.4 and 30.5 mg/dL, ALT 65 and 96 U/L, Alk P 202 and 398 U/L], resulting in death in one and emergency liver transplant in the other [Case 1]). 26325535
Marchan-Lopez A, Dominguez-Dominguez L, Kessler-Saiz P, Jarrin-Estupiñan ME. Liver failure in human immunodeficiency virus - hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy. J Hepatol 2016; 64: 752-3. (Letter in response to Dyson [2016]: 49 year old man with chronic hepatitis C, cirrhosis [Child-Pugh class B] and HIV coinfection developed worsening hepatic decompensation 1 to 2 months after starting sofosbuvir and ledipasvir that worsened for two weeks after stopping [peak bilirubin 46.9 mg/dL, INR 3.17], and then resolved; he later tolerated reinitiation of antiretroviral drugs). 26682727
Dyson JK, McPherson S. Reply to "Liver failure in human immunodeficiency virus - Hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy". J Hepatol 2016; 64: 753-4. (Letter in reply to March-Lopez [2016] reporting another case of hepatic decompensation during sofosbuvir, ledipasvir and ribavirin therapy of a patient hepatitis C, cirrhosis and HIV coinfection, arising within 6 weeks of starting treatment [bilirubin 12.6 mg/dL, protime 17 sec], and leading to successful, emergency liver transplantation). 26682725
Welker MW, Luhne S, Lange CM, Vermehren J, Farnik H, Herrmann E, Welzel T, et al. Lactic acidosis in patients with hepatitis C virus cirrhosis and combined ribavirin/ sofosbuvir treatment. J Hepatol 2016; 64; 790-8. (Among 35 patients with chronic hepatitis C and advanced fibrosis or cirrhosis treated with sofosbuvir based regimens, 12 [34%] had a serious adverse event and 5 [14%] developed lactic acidosis, largely in those with Child-Pugh class B or C cirrhosis and in the context of hepatic decompensation, 2 of whom died). 26658684
Hoofnagle JH. Hepatic decompensation during direct-acting antiviral therapy of chronic hepatitis C. J Hepatol 2016; 64: 763-5. (Editorial in response to Welker [2016] discussing the occurrence of unexplained hepatic decompensation during antiviral therapy of hepatitis C and whether these episodes are coincidental, caused by hepatoxicity of the antiviral drugs, or are the paradoxical result of sudden eradication of the chronic viral infection). 26795828
Alonso S, Riveiro-Barciela M, Fernandez I, Rincón D, Real Y, Llerena S, Gea F, et al. Effectiveness and safety of sofosbuvir-based regimens plus an NS5A inhibitor for patients with HCV genotype 3 infection and cirrhosis. results of a multicenter real-life cohort. J Viral Hepat 2017; 24: 304-11. (Among 208 cirrhotic patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and either daclatasvir or lepidasvir with or without ribavirin, the overall SVR rate was 94% and 7 patients developed hepatic decompensation, 3 of whom died). 27935168
Sperl J, Horvath G, Halota W, Ruiz-Tapiador JA, Streinu-Cercel A, Jancoriene L, Werling K, et al. Efficacy and safety of elbasvir/grazoprevir and sofosbuvir/pegylated interferon/ribavirin: A phase III randomized controlled trial. J Hepatol 2016; 65: 1112-9. (Among 257 patients with chronic hepatitis C, genotypes 1 and 4, SVR rates were 99% with 12 weeks of elbasvir and grazoprevir and 90.5% with 12 weeks of sofosbuvir, peginterferon and ribavirin; adverse events were more frequent in the interferon treated subjects, but there were no deaths and no liver related serious adverse events or late ALT elevations). 27542322
Feld JJ, Maan R, Zeuzem S, Kuo A, Nelson DR, Di Bisceglie AM, Manns MP, et al. Effectiveness and safety of sofosbuvir-based regimens for chronic HCV genotype 3 infection: results of the HCV-TARGET Study. Clin Infect Dis 2016; 63: 776-83. (Among 178 patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and ribavirin, the overall response rate was 60% and 11 patients had a decompensation event, arising 0.1 to 24 weeks after starting, all with a previous history of decompensation). 27325691
Gane EJ, Shiffman ML, Etzkorn K, Morelli G, Stedman C, Davis MN, Hinestrosa F, et al; GS-US-342-1553 Investigators. Sofosbuvir-velpatasvir with ribavirin for 24 weeks in HCV patients previously treated with a direct-acting antiviral regimen. Hepatology 2017; 66: 1083-9. (Among 69 patients with chronic hepatitis C who had failed to respond to a course of direct acting antiviral therapy and were treated with a 24-week course of sofosbuvir-velpatasvir and ribavirin, the SVR rate was 91% and adverse events were largely due to ribavirin and there were no ALT elevations after the initial decrease). 28498551

## OTHER REFERENCE LINKS

1. Recent References on Ribavirin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ribavirin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ribavirin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ribavirin)